# Maca

## OVERVIEW

### Introduction

Maca is a vegetable and food as well as a traditional herbal medicine derived from the roots of a perennial plant (Lepidium meyenii) that grows in high altitudes of Peru and is used to promote health and improve wellness, sexual function and fertility. Maca has not been implicated in causing liver injury either in the form of transient serum enzyme elevations or clinically apparent liver injury.

### Background

Maca (ma' ka) is a food and traditional herbal medicine derived from the roots of a perennial plant (Lepidium meyenii) cultivated at high altitudes in the Andes mountains. Also known as “Peruvian ginseng” is belongs to the genus Lepidium and family Brassica (mustard). Maca is unique in being one of the few edible plants that can survive the intense cold, sunlight and strong winds found above 4000 m in the Peruvian Andes. In Peru, maca has been used for centuries as a food supplement to improve health and for its medicinal properties to enhance energy and fertility. The principal and edible part of the maca plant is the underground tuber, which is similar to a radish or turnip and varies in size and color (white, black, red). The principal components of maca are carbohydrates and protein and it is an excellent source of essential amino acids, iron and calcium. Secondary components include macaridine, macaenes, macamides and maca alkaloids that are unique to this plant. It also has multiple sterols and glucosinolates. In experimental animals, maca extracts increase sexual function and improve fertility. Other activities include improvement in memory and learning, decrease in prostate size and improvement in bone mineralization. Studies in humans have had conflicting results, but it has been promoted as improving sexual desire and improving sperm counts, improving mood, memory and learning, as well as energy and physical stamina. None of these effects have been proven in prospective, rigorously controlled trials in humans. The recommended daily dose varies widely (500 to 3000 mg daily), depending on the preparation used (capsules, tablets, liquid, root extract) and indications. Side effects of maca are uncommon and mild, and mostly include gastrointestinal symptoms and headaches.

### Hepatotoxicity

In small clinical trials, maca extracts have been reported to be safe, well tolerated and with only minor, transient adverse effects. There have been no convincing reports linking maca to liver injury, either in the form of transient serum enzyme elevations during therapy or clinically apparent acute liver injury. As an herbal supplement, however, maca has had limited use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Maca – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/555.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Maca | M010010000 (https://chem.sis.nlm.nih.gov/chemidplus/direct.jsp?regno=M010010000) | Herbal Extract | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; maca is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of HDS; maca is not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; maca is not listed as causing hepatotoxicity).
Gonzales GF, Córdova A, Vega K, Chung A, Villena A, Góñez C. (2003). Effect of Lepidium meyenii (Maca), a root with aphrodisiac and fertility-enhancing properties, on serum reproductive hormone levels in adult healthy men. J Endocrinol. (Among 56 adult men treated with maca [1.5 or 3.0 g daily] for up to 12 weeks, sex and pituitary hormone levels did not change; adverse events were not reported).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to maca).
Valerio LG, Gonzales GF. (2005). Toxicological aspects of the South American herbs cat's claw (Uncaria tomentosa) and Maca (Lepidium meyenii): a critical synopsis. Toxicol Rev. (Extensive review of the pharmacological and toxicological features of two popular South American traditional remedies, maca and cat’s claw, the former having a long history of medicinal use in traditional medicine by indigenous cultures but has not been well studied scientifically, although studies in experimental animals suggest a low degree of oral toxicity).
Dording CM, Fisher L, Papakostas G, Farabaugh A, Sonawalla S, Fava M, Mischoulon D. (2008). A double-blind, randomized, pilot dose-finding study of maca root (L. meyenii) for the management of SSRI-induced sexual dysfunction. CNS Neurosci Ther. (Open label study of two doses of maca in 16 patients with antidepressant induced sexual dysfunction found improvements with the higher [3 g] but not lower [1.5 g] daily doses and mentions that maca was “well tolerated overall”, the most frequent side effect being gastrointestinal [31%]).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, but none were attributed to maca).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry between 1987 and 2006 found no cases attributed to maca).
Shin BC, Lee MS, Yang EJ, Lim HS, Ernst E. (2010). Maca (L. meyenii) for improving sexual function: a systematic review. BMC Complement Altern Med. (A systematic review of the literature on maca for improving sexual function provided “limited evidence” for its effectiveness and none of the trials provided information on adverse events).
Lee MS, Shin BC, Yang EJ, Lim HJ, Ernst E. (2011). Maca (Lepidium meyenii) for treatment of menopausal symptoms: a systematic review. Maturitas. (Systematic review of the literature on use of maca for menopausal symptoms identified 4 controlled trials all of which demonstrated “favorable” effects but the number, size and quality of the studies “were too limited to draw firm conclusions”).
Gonzales GF. (2012). Ethnobiology and ethnopharmacology of Lepidium meyenii (maca), a plant from the Peruvian highlands. Evid Based Complement Alternat Med. (Review of the history and tradition of use of maca, its chemical constituents and results of studies in experimental animals and clinical trials in humans mentions that studies in rats have revealed no toxic effects and it has been reported to be safe in humans).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements; does not list maca).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not discuss maca).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a known maca containing product).
Stojanovska L, Law C, Lai B, Chung T, Nelson K, Day S, Apostolopoulos V, et al. (2015). Maca reduces blood pressure and depression, in a pilot study in postmenopausal women. Climacteric. (Among 29 postmenopausal women treated with maca [3.3 g] or placebo daily for 6 weeks in a cross-over study, hormonal levels, glucose, lipids and sexual dysfunction scores did not change, while depression and anxiety scores improved to a similar extent with maca and placebo).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver does not mention or discuss maca).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci. (Listing of published cases of liver injury from HDS products does not mention or discuss maca in the listings).
Gonzales-Arimborgo C, Yupanqui I, Montero E, Alarcón-Yaquetto DE, Zevallos-Concha A, Caballero L, Gasco M, et al. (2016). Acceptability, safety, and efficacy of oral administration of extracts of black or red maca (Lepidium meyenii) in adult human subjects: a randomized, double-blind, placebo-controlled study. Pharmaceuticals(Basel). (Among 175 adults given 3 g of red or black maca or placebo daily for 12 weeks, improvements in sexual desire, mood and energy and health related quality of life were greater with maca; adverse events were not discussed).
Xiao A, He HY, Chen Q, Ma SW. (2017). Drug-induced liver injury due to Lepidium meyenii (Maca) medicinal liquor. Chin Med J (Engl). (30 year old man developed jaundice within a few days of drinking 300 mL of “maca medicinal liquor” [bilirubin 4.9 mg/dL, ALT 1886 U/L, Alk P 136 U/L, INR 1.1], with resolution over the next 1-3 months).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products; does not mention maca).
Wong LL, Lacar L, Roytman M, Orloff SL. (2017). Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products, but maca was not implicated in any case).

## OTHER REFERENCE LINKS

1 Recent References on Maca: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Maca/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Maca: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Maca)